# Severity Grading In Drug Induced Liver Injury

The severity of cases of drug induced liver injury can vary greatly, from mild, transient and asymptomatic elevations in serum enzyme levels to acute liver failure leading rapidly to death or need for liver transplantation. In assessing drug induced liver injury, it is important to categorize severity in an objective manner. However, the variability in manifestations of drug induced liver disease makes it difficult to use a single symptom, laboratory abnormality or outcome to grade severity of injury. As a part of ongoing studies of drug induced liver injury, the Drug-Induced Liver Injury Network (DILIN) developed a 5 point scale for grading the severity of liver injury based upon the presence of jaundice, hospitalization, signs of hepatic or other organ failure, and ultimate outcome.

- 1+, Mild: Raised serum aminotransferase or alkaline phosphatase levels or both, but total serum bilirubin <2.5 mg/dL and no coagulopathy (INR <1.5)
- 2+, Moderate: Raised serum aminotransferase or alkaline phosphatase levels or both [underlined: and] total serum bilirubin level ≥2.5 mg/dL [underlined: or] coagulopathy (INR ≥1.5) without hyperbilirubinemia
- 3+, Moderate to Severe: Raised serum aminotransferase or alkaline phosphatase levels and total serum bilirubin level ≥2.5 mg/dL [underlined: and] hospitalization (or preexisting hospitalization is prolonged) because of the drug induced liver injury
- 4+, Severe: Raised serum aminotransferase or alkaline phosphatase levels and serum bilirubin ≥2.5 mg/dL [underlined: and] at least one of the following:
  - Prolonged jaundice and symptoms beyond 3 months, [underlined: or]
  - Signs of hepatic decompensation (INR ≥1.5, ascites, encephalopathy), [underlined: or]
  - Other organ failure believed to be related to drug induced liver injury
- 5+, Fatal: Death or liver transplantation for drug induced liver injury

Severity is also graded on the basis of symptoms, with “S” indicating symptoms believed to be caused by the liver injury and “A” absence of symptoms. Symptoms that qualify as possibly due to liver injury include fatigue, weakness, nausea, right upper quadrant pain, itching, skin rash, jaundice, anorexia or weight loss. In all situations, the symptoms should be judged as being due to the drug induced liver injury. This grading applies mostly to patients with enzyme elevations without jaundice, as it is rare for a patient with jaundice not to have symptoms.

In prospective clinical trials of medications, standard criteria are used to assess the severity of adverse events including symptoms and laboratory test abnormalities. Adverse events are typically graded on a scale of 0 to 4. Grades for severity of liver test abnormalities and symptoms of liver injury have been developed and standardized and are used in many publications of clinical trials and studies of new medications. A commonly used grading system is that developed by the Acquired Immune Deficiency Syndrome (AIDS) Clinical Trials Group (CTG). In this system, the following levels are used to assess severity, with the values expressed as multiples of the upper limit of the normal range (ULN).

FEATURE | Grade 0 | Grade 1 | Grade 2 | Grade 3 | Grade 4
ALT | <1.25 | 1.25-2.5 | >2.5-5.0 | >5.0-10 | >10
AST | <1.25 | 1.25-2.5 | >2.5-5.0 | >5.0-10 | >10
Alkaline Phosphatase | <1.25 | 1.25-2.5 | >2.5-5.0 | >5.0-10 | >10
GGT | <1.25 | 1.25-2.5 | >2.5-5.0 | >5.0-10 | >10
Bilirubin | Normal | >1.0-1.5 | >1.5-2.5 | >2.5-5 | >5

Descriptive terms are also applied to these grades, with Grade 1 indicating mild, Grade 2 moderate, and Grade 3 severe and Grade 4 life-threatening values. However, it should be stressed that these terms usually overestimate the severity of drug induced liver injury, as ALT levels of 5 to 10 times the upper limit of normal (~200 to 400 U/L) without symptoms or jaundice cannot be considered severe hepatotoxicity, and should instead be referred to as “Grade 3 ALT elevations”. The grading of liver test elevations is sometimes adjusted to baseline values, particularly in patients with underlying liver disease, such as hepatitis B or C. In these situations, Grade 0 represents values <1.25, Grade 1, 1.25-2.5, Grade 2, 2.6-3.5, Grade 3, 3.6-5, and Grade 4, >5 times baseline. This convention, however, is not always used.

A similar grading system has been developed by the Cancer Therapy Evalutation Program of the National Cancer Institute (NCI) of the National Institutes of Health, which is referred to as the Common Toxicity Criteria for Adverse Events, version 4.0: CTCAEv4.03. In this system, the following levels are used to assess severity, with the values expressed as multiples of the upper limit of the normal range (ULN).

FEATURE | Grade 0 | Grade 1 | Grade 2 | Grade 3 | Grade 4
ALT | Normal | >1.0-3.0 | >3.0-5.0 | >5.0-20 | >20
AST | Normal | >1.0-3.0 | >3.0-5.0 | >5.0-20 | >20
Alkaline Phosphatase | Normal | >1.0-2.5 | >2.5-5.0 | >5.0-20 | >20
GGT | Normal | >1.0-2.5 | >2.5-5.0 | >5.0-20 | >20
Bilirubin | Normal | >1.0-1.5 | >1.5-3.0 | >3.0-10 | >10

Descriptive terms are also applied to these grades, with Grade 1 indicating mild, Grade 2 moderate, and Grade 3 severe and Grade 4 life-threatening values. However, it should be stressed that these terms usually overestimate the severity of drug induced liver injury, as ALT levels of 5 to 20 times the upper limit of normal (~400 to 800 U/L) without symptoms or jaundice cannot be considered severe hepatotoxicity, and should instead be referred to as “Grade 3 ALT elevations”. The grading of liver test elevations is sometimes adjusted to baseline values, particularly in patients with underlying liver disease, such as hepatitis B or C. In these situations, Grade 0 represents values <1.00, Grade 1, 1.00-2.5, Grade 2, 2.6-5.0, Grade 3, 5.0-20, and Grade 4, >20 times baseline. This convention, however, is not always used.

Thus, the two grading systems have slightly different "cutpoints" to separate the different grades of injury. The AIDS Clinical Trials Group requires an enzyme elevation of at least 1.25 times the ULN to warrant the designation of Grade 1 abnormalities, whereas the NCI system uses any elevation above the ULN as Grade 1 enzyme abnormalities. Similarly, Grade 4 abnormalities in the AIDS CTG system are based on enzyme values above 10 times the ULN, whereas the NCI system uses 20 times ULN.

A problem with all grading systems using the upper limit of normal as an index is that there is little consensus on what the ULN should be or how it should be calculated. Thus, the upper limit of normal of ALT in different testing laboratories can range from 19 to 77 U/L, and some laboratories use a different reference range for women than men. Actually, current automated systems for measuring ALT values yield very similar results and use of common reference limits is reasonable, particularly in multicenter trials. In the LiverTox website, the default ULN for ALT is 40 U/L, alkaline phosphatase 115 U/L and bilirubin 1.2 mg/dL. Serum bilirubin values are particularly confusing when using multiples of the upper limit of normal, as the ULN in different laboratories may be 1.0, 1.2, or 1.5 mg/dL and a Grade 4 elevation may therefore be 10 mg/dL, 12 mg/dL or 15 mg/dL.